# Marijuana

## OVERVIEW

### Introduction

Marijuana is an extract from the twigs, seeds and fruit of the Cannabis sativa plant which is widely used for its psychoactive effects and is illegal in many areas of the world including at least half of the United States. Recently, marijuana has been purported to have beneficial medicinal effects including antiemetic, analgesic, anxiolytic, sedative, sleep inducing, and antidepressant activities. Marijuana use has not been linked to serum enzyme elevations during therapy or to instances of clinically apparent liver injury with jaundice.

### Background

Marijuana (mare” a wan’ a) is a psychoactive extract of the small twigs, seeds and fruit of female marijuana plants (Cannabis sativa), a large, hardy, annual or biennial plant that originated from the Middle East but is now found worldwide in temperate and tropical areas. While marijuana is often referred to as cannabis, the term cannabis actually refers to all Cannabis sativa products, both psycho-active and -neutral. More than 50 cannabinoids have been identified in Cannabis sativa extracts, but the most abundant is delta-9 tetrahydrocannabinol (THC) which appears to be the major psychoactive component of marijuana. THC binds to the cannabinoid receptors that are found in the central nervous system (CB1 receptors), but also the periphery (largely CB2 receptors). Activation of CB receptors results in potent effects on appetite, mood, cognition, memory and perception and possibly on pain, inflammatory, and metabolic pathways. Purified or synthetic THC are the main components of dronabinol and nabilone, FDA approved prescription drugs that are used for the treatment of the nausea and vomiting associated with anticancer therapy and for anorexia and weight loss in patients with AIDS. Cannabis and THC preparations have multiple physiological effects besides antiemetic and appetite stimulating actions, including sedation, reduction of anxiety and restlessness, and decrease in intraocular pressure. Less well established effects include use as a muscle relaxant or analgesic and as treatment for depression, epilepsy and Tourette syndrome. Cannabis also causes euphoria and altered mentation and is widely used recreationally for these effects. Marijuana and most cannabinoids are poorly absorbed by mouth and subject to first pass uptake by the liver, for which reason it is typically smoked or vaped which gives it maximal systemic exposure. Sale of marijuana or THC is banned in many countries including by the US Federal Government. Nevertheless, it is legalized for production and sale within several states. Recently, medical marijuana has been approved in some countries and parts of the United States generally for conditions such as chronic pain, nausea and vomiting, arthritis, anxiety and depression. Similarly, recreational marijuana has now been decriminalized and even legalized in many countries and States of the Union. However, US Federal laws still label cannabis as an illegal drug, outlaw its interstate commerce, and not proven to have medical effectiveness for any disease or condition. Marijuana is available in multiple forms, including extracts or solutions for smoking and vaping, in foods and gummies, and as powders, dry extracts, tablets or capsules. These forms of cannabis are available over-the-counter or as illegal products but are generally of uncertain purity, potency and safety. Common side effects include fatigue, sedation, somnolence, dizziness, euphoria, abnormal thinking, paranoid reactions, impairment of driving and operation of heavy equipment, conjunctivitis, diarrhea, nausea, vomiting, abdominal pain, orthostatic hypotension and tachycardia. Rare side effects include hallucinations and seizures. Marijuana, THC and cannabis have a clear potential for physical and psychological dependency and abuse, sometimes referred to as cannabis use disorder.

### Hepatotoxicity

The frequency and severity of serum enzyme and bilirubin elevations during cannabis use are not well defined, but in small prospective studies, no biochemical abnormalities were found with its use. Furthermore, while rare case reports of acute liver injury attributed to marijuana have been reported, none were convincing or well documented. In large case series of drug and herbal supplement induced liver injury, cannabis and marijuana have not been implicated. In large epidemiologic studies of populations, cannabis use has been repeatedly linked to liver abnormalities, but all such studies were retrospective and uncontrolled, particularly for the presence of other causes of chronic liver injury. Careful, prospective controlled studies are needed to resolve the issue, but at present cannabis does not appear to cause acute liver injury or to exacerbate preexisting liver disease.

Likelihood score: E (Unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Cannabis is metabolized by the liver by the microsomal cytochrome P450 system, predominant CYP 2D6 and 3A4. It is not well absorbed orally and undergoes extensive first-pass metabolism to both active and inactive metabolites. Despite its hepatic metabolism, it has not been implicated in causing clinically significant drug-drug interactions. The lack of reported convincing cases of liver injury and low rate of drug-drug interactions due to cannabis may be due to the low doses and limited duration of typical therapy.

Other names: Grass, Indian Hemp, Pot, Weed, Mary Jane

Drug Class: Sedatives and Hypnotics, Antiemetic Agents

Other Related Cannabinoid Agents: Dronabinol, Nabilone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Marijuana – Generic

DRUG CLASS

Antiemetic Agents

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Δ9Tetrahydrocannabinol | 16849-50-6 (https://pubchem.ncbi.nlm.nih.gov/compound/2978) | C21-H30-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 16 February 2023

Abbreviations used: C AIDS, acquired immune deficiency syndrome; B, cannabinoids; CBD, cannabidiol; THC, Δ^9^ tetrahydrocannabinol.

Zimmerman HJ. Antiemetic and prokinetic compounds. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Expert review of hepatotoxicity published in 1999 does not discuss cannabis or marijuana).
Sharkey KA, MacNaughton WK. Antinauseants and antiemetics. Gastrointestinal motility bowel motility and water flux, emesis, and biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 934-8. (Textbook of pharmacology and therapeutics).
Marijuana. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 562-7. (Compilation of short monographs on herbal medications and dietary supplements, in the discussion of adverse events associated with cannabis there is no mention of hepatotoxicity).
NCCIH. https://www.nccih.nih.gov/health/cannabis-marijuana-and-cannabinoids-what-you-need-to-know (Website of the National Center for Complementary and Integrated Health [NCCIH], which includes factsheets on many herbal products including marijuana, with descriptions of its potential clinical effects and risks of side effects).
Kew MC, Bersohn I, Siew S. (1969). Possible hepatotoxicity of cannabis. Lancet. (Letter to the editor describing a 21 year old man with cirrhosis of unknown cause who was a frequent user of marijuana; testing of 12 frequent marijuana users revealed mild, nonspecific elevations in liver related tests in 8 which were not explained by other diagnoses).
Borini P, Guimarães RC, Borini SB. (2004). Possible hepatotoxicity of chronic marijuana usage. Sao Paulo Med J. (Among 123 marijuana users, liver test abnormalities were frequent, including serum ALT elevations in 34% of those who used marijuana only and 71% of those who also drank alcohol; the liver abnormalities were mostly mild and without jaundice or symptoms; no mention of tests for hepatitis B or C).
Hézode C, Roudot-Thoraval F, Nguyen S, Grenard P, Julien B, Zafrani ES, Pawlotsky JM, et al. (2005). Daily cannabis smoking as a risk factor for progression of fibrosis in chronic hepatitis C. Hepatology. (Among 270 patients with chronic hepatitis C undergoing liver biopsy and evaluation for marijuana use and alcohol intake, daily cannabis use was associated with more advanced fibrosis; other risk factors were disease activity, duration of infection, genotype 3, steatosis, and alcohol intake).
Hézode C, Zafrani ES, Roudot-Thoraval F, Costentin C, Hessami A, Bouvier-Alias M, Medkour F, et al. (2008). Daily cannabis use: a novel risk factor of steatosis severity in patients with chronic hepatitis C. Gastroenterology. (Among 315 patients with chronic hepatitis C undergoing liver biopsy and evaluation for marijuana use and alcohol intake, daily cannabis smoking was independently associated with hepatic steatosis even after controlling for alcohol intake and genotype 3 infection).
Ishida JH, Peters MG, Jin C, Louie K, Tan V, Bacchetti P, Terrault NA. (2008). Influence of cannabis use on severity of hepatitis C disease. Clin Gastroenterol Hepatol. (Among 204 patient with chronic hepatitis C undergoing liver biopsy, daily cannabis use was associated with more advanced fibrosis in multivariant analysis).
Le Strat Y, Le Foll B. (2011). Obesity and cannabis use: results from 2 representative national surveys. Am J Epidemiol. (Analysis of two national surveys demonstrated a lower prevalence of obesity among frequent marijuana users than in non-users [14.3% vs 22% in survey 1 and 27.2% vs 25.3% in survey 2]).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no cases were attributed to marijuana or other cannabinoids).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none of these were attributed to marijuana or other cannabinoids).
Swarnalatha G, Pai S, Ram R, Dakshinamurty KV. (2013). Fulminant hepatic failure following marijuana drug abuse: Molecular adsorbent recirculation system therapy. Indian J Nephrol. (23 year old male developed fatigue followed by acute liver failure [bilirubin 13 mg/dL, ALT 1346 U/L, Alk P 508 U/L, protime time 85 seconds] with recovery after treatment with a molecular adsorbent recirculation system [MARS], liver injury being attributed to marijuana because of a positive urine test for THC and absence of evidence for another cause).
Borgelt LM, Franson KL, Nussbaum AM, Wang GS. (2013). The pharmacologic and clinical effects of medical cannabis. Pharmacotherapy. (Review of history and status of cannabis used for medical purposes including severe pain, muscle spasms, anorexia, nausea and vomiting, and glaucoma; adverse events were common, but usually mild and reversible, most frequently dry mouth, dizziness, drowsiness, and changes in cognition and mood).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to cannabis or other cannabinoid).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13], and flutamide [n=12: 7%]; no cannabinoid was listed).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to marijuana or cannabis).
Sheikh IA, Lukšič M, Ferstenberg R, Culpepper-Morgan JA. (2014). Spice/K2 synthetic marijuana-induced toxic hepatitis treated with N-acetylcysteine. Am J Case Rep. (45 year old man developed acute hepatitis a week after starting the synthetic recreational marijuana “Spice/K2” [initial bilirubin 0.7 rising to 7.0 mg/dL, ALT 799 rising to 4136U/L, Alk P 260 U/L], with recovery over the next two weeks).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to cannabis or other cannabinoids).
Whiting PF, Wolff RF, Deshpande S, Di Nisio M, Duffy S, Hernandez AV, Keurentjes JC, et al. (2015). Cannabinoids for medical use: a systematic review and meta-analysis. JAMA. (A systematic review of 79 studies of the medical use of cannabinoids for various conditions, found evidence of benefit in most trials, but differences from placebo often did not reach statistical significance; rates of response in trials for nausea and vomiting were 47% vs 20% and for pain were 37% vs 31%, while adverse events were generally more frequent with cannabinoids, most frequently dizziness, dry mouth, fatigue, nausea, somnolence, euphoria, disorientation, drowsiness, confusion, ataxia and hallucinations; no mention of ALT elevations or hepatotoxicity).
Adejumo AC, Alliu S, Ajayi TO, Adejumo KL, Adegbala OM, Onyeakusi NE, Akinjero AM, et al. (2017). Cannabis use is associated with reduced prevalence of non-alcoholic fatty liver disease: A cross-sectional study. PLoS One. (A population based case-control study of patients using the Healthcare Cost and Utilization Project Nationwide Inpatient Sample demonstrated a lower rate of nonalcoholic fatty liver disease in cannabis users, particularly cannabis dependent patients suggesting that its use might lessen fatty liver disease injury).
Adejumo AC, Adegbala OM, Adejumo KL, Bukong TN. (2018). Reduced incidence and better liver disease outcomes among chronic HCV infected patients who consume cannabis. Can J Gastroenterol Hepatol. (A case-control study of patients using the Healthcare Cost and Utilization Project Nationwide Inpatient Sample between 2007 and 2014 demonstrated a lower rate of cirrhosis among hepatitis C virus infected individuals who were cannabis users, although rates of hepatocellular carcinoma and HCV related deaths were similar in users as non-users).
Adejumo AC, Ajayi TO, Adegbala OM, Adejumo KL, Alliu S, Akinjero AM. (2018). Cannabis use is associated with reduced prevalence of progressive stages of alcoholic liver disease. Liver Int. (A population based case-control study of patients using the 2014 Healthcare Cost and Utilization Project Nationwide Inpatient Sample demonstrated lower rate of alcoholic steatosis, steatohepatitis, cirrhosis and hepatocellular carcinoma among patients with alcohol use disorder who were also cannabis users, although the effect was not seen in patients with the highest daily alcohol intake).
Polito S, MacDonald T, Romanick M, Jupp J, Wiernikowski J, Vennettilli A, Khanna M, et al. (2018). Safety and efficacy of nabilone for acute chemotherapy-induced vomiting prophylaxis in pediatric patients: A multicenter, retrospective review. Pediatr Blood Cancer. (Among 110 pediatric patients treated with nabilone for prevention of chemotherapy induced nausea and vomiting [usually in combination with a serotonin [5-HT3] receptor antagonist], adverse events arose in 34%, most commonly sedation [20%], dizziness [10%] and euphoria [4%], leading to discontinuation in 9%, but without serious adverse events; no mention of ALT elevations or hepatotoxicity).
Stockings E, Campbell G, Hall WD, Nielsen S, Zagic D, Rahman R, Murnion B, et al. (2018). Cannabis and cannabinoids for the treatment of people with chronic noncancer pain conditions: a systematic review and meta-analysis of controlled and observational studies. Pain. (Systematic review of 91 publications including 104 studies and 9958 participants in trials of cannabinoids for pain reduction reported significant pain reduction in 29% of cannabinoid recipients vs 26% of placebo recipients, although adverse event rates were higher with cannabis products; no mention of specific adverse events, ALT elevations or hepatotoxicity).
Torres-Moreno MC, Papaseit E, Torrens M, Farré M. (2018). Assessment of efficacy and tolerability of medicinal cannabinoids in patients with multiple sclerosis: a systematic review and meta-analysis. JAMA Netw Open. (A systematic review of 17 randomized controlled trials of various cannabinoids in multiple sclerosis found limited therapeutic efficacy for spasticity, pain and bladder dysfunction and higher rates of adverse events including dizziness, dry mouth, fatigue, ataxia, impaired memory, and somnolence, but similar rates of severe adverse events; no mention of ALT elevations or hepatotoxicity).
Herrmann N, Ruthirakuhan M, Gallagher D, Verhoeff NPLG, Kiss A, Black SE, Lanctôt KL. (2019). Randomized placebo-controlled trial of nabilone for agitation in Alzheimer's Disease. Am J Geriatr Psychiatry. (Among 38 elderly patients with Alzheimer disease treated with nabilone [titrated] or placebo for 6 weeks in a cross-over trial, nabilone therapy was associated with a slight decrease in agitation but increase in sedation; no mention of ALT elevations or hepatoxicity).
(2019). Cannabis and cannabinoids. Med Lett Drugs Ther. (Concise review of the beneficial and adverse effects of cannabis and cannabinoids, 3 of which are FDA approved products, two synthetic agents that are used for prevention of chemotherapy induced nausea and vomiting [nabilone and dronabinol] and one a purified natural product used to treat rare forms of severe epilepsy [cannabidiol]; cannabis can cause dizziness, somnolence, euphoria, abnormal thinking, difficulty concentrating, hypotension, hypertension, syncope and tachycardia as well as addiction and dependence with long term use; no mention of ALT elevations or hepatoxicity).
Bar-Lev Schleider L, Mechoulam R, Saban N, Meiri G, Novack V. (2019). Real life experience of medical cannabis treatment in autism: analysis of safety and efficacy. Sci Rep. (Among 188 patients with autism spectrum disorders treated with miscellaneous cannabis products [usually consisting of 30% CBD and 1.5% THC, given 3 times daily] between 2015 and 2017 in Israel, 49% reported significant improvement, 31% moderate improvement, 6% side effects and 14% no change; no mention of ALT elevations or hepatotoxicity).
(2019). Drugs for anxiety disorders. Med Lett Drugs Ther. (Concise review of drugs used to treat anxiety including cannabidiol products which are marketed as effective but “their potency, purity, efficacy and safety are unknown”).
Chesney E, McGuire P, Freeman TP, Strang J, Englund A. (2020). Lack of evidence for the effectiveness or safety of over-the-counter cannabidiol products. Ther Adv Psychopharmacol. (Extensive review of the efficacy and safety of cannabidiol compares pharmaceutical grade to over-the-counter grade products, most of which are of uncertain purity and concentration and are used in lower doses [<300 mg/day], which are unlikely to achieve plasma levels associated with engagement of cannabinoid receptors and which have not consistently shown the effects of the higher doses of pharmaceutical grade cannabidiol that has been shown to reduce anxiety and psychiatric symptoms but also cause liver enzyme elevations, particularly when given with clobazam or valproate).
Sholler DJ, Huestis MA, Amendolara B, Vandrey R, Cooper ZD. (2020). Therapeutic potential and safety considerations for the clinical use of synthetic cannabinoids. Pharmacol Biochem Behav. (Extensive review of the endocannabinoid system and potential therapies for synthetic cannabinoids [CB] and CB receptor antagonists; while there are CB receptors in the liver [predominantly CB2], there is no evidence that the CBs in clinical practice cause liver injury).
Grimison P, Mersiades A, Kirby A, Lintzeris N, Morton R, Haber P, Olver I, et al. (2020). Oral THC:CBD cannabis extract for refractory chemotherapy-induced nausea and vomiting: a randomised, placebo-controlled, phase II crossover trial. Ann Oncol. (Among 81 patients with refractory chemotherapy induced nausea and vomiting were treated with 1 to 4 oral cannabis extract tablets [THC 2.5 mg/CBD 2.5 mg] or placebo three times daily 1 day before and 5 days after chemotherapy in a crossover design, a complete response [no nausea or vomiting] occurred in 25% of THC/CBD treated compared to 14% of placebo treated courses; adverse events more frequent with THC/CBD included sedation, dizziness, and disorientation, but there were no cannabinoid related serious adverse events and no mention of ALT elevations or hepatotoxicity).
Bouquet E, Pain S, Eiden C, Jouanjus E, Richard N, Fauconneau B, Pérault-Pochat MC, French Addictovigilance Network. (2021). Adverse events of recreational cannabis use reported to the French Addictovigilance Network (2012-2017). Br J Clin Pharmacol. (Among 2217 patients enrolled in a French vigilance registry of addiction involving cannabis use between 2012 and 2017, most were men [76%], and 18 to 34 years old [57%], the most frequent adverse events were psychiatric [51%], neurological [37%], cardiac [8%], and cannabinoid hyperemesis syndrome [3%], with only 3 being hepatobiliary events [abscess, sclerosing cholangitis and “cytolysis”], with no unexpected hepatic events, or deaths from liver disease).
Watkins PB, Church RJ, Li J, Knappertz V. (2021). Cannabidiol and abnormal liver chemistries in healthy adults: results of a phase I clinical trial. Clin Pharmacol Ther. (Among 16 healthy volunteers treated with cannabidiol in doses of 1500 mg daily for 3 to 4 weeks, 7 [44%] developed ALT elevations which were greater than 5 times ULN in 5 [31%] beginning with 2-4 weeks and resolving rapidly with discontinuation; no mention of bilirubin elevations but alkaline phosphatase elevations occurred as well and some patients developed symptoms or signs of hepatitis including fever, nausea, abdominal discomfort, and eosinophilia).
Yan K, Forman L. (2021). Cannabinoid use among liver transplant recipients. Liver Transpl. (Among 1227 liver transplant recipients, 538 responded to an exploratory survey on cannabinoid use, 24% were using marijuana [72% smoking, 47% daily use] and 21% were using CBD, usually for relieving pain [85%] and anxiety [31%]; the effects of liver tests and transplant outcomes could not be assessed).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases of liver injury due to 79 different herbal products, the most common being He Shou Wu [n=91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; cannabis and marijuana were no listed).
Abosheaishaa H, Nassar M, Haseeb Ul Rasool M, Makhoul K, Abdelwahed M. (2022). Marijuana-induced acute hepatitis: a case report. Cureus. (34 year old African American woman developed nausea and vomiting and was found to have abnormal liver tests [bilirubin 0.6 mg/dL, ALT 411 U/L, AST 2636 U/L, Alk P 411 U/L, INR 1.1] and a history of marijuana use and positive urine screening test for THC, with no other obvious cause of the liver injury).
Abelev S, Warne LN, Benson M, Hardy M, Nayee S, Barlow J. (2022). Medicinal cannabis for the treatment of chronic refractory pain: an investigation of the adverse event profile and health-related quality of life impact of an oral formulation. Med Cannabis Cannabinoids. (Among 151 adults with chronic pain treated with an oil-based mixture of THC and CBD, pain scores improved minimally and 60% of patients had adverse events, none of which were serious; no mention of ALT elevations or hepatotoxicity).
EFSA Panel on Nutrition. (2022). Statement on safety of cannabidiol as a novel food: data gaps and uncertainties. EFSA J. (Major review of the mechanisms of action, clinical effects and toxicities of cannabidiol [CBD] used as a “novel food” in the European Union, difficulties being the variable purity and concentration of commercial CBD products, its uncertain mechanism of action, the lack of rigorous clinical studies of its efficacy, and poor description of potential toxicities leading to the conclusion that more and better studies are needed; in animal models CBD increases the relative liver weight and has variably been found to result in transient elevations in ALT, Alk P and bilirubin; similar results have been found in healthy human volunteers, but largely in higher doses and without instances of clinically apparent liver injury).
Nathan R, Mupamombe CT, Elibol J, Case AA, Smith D, Hyland A, Attwood K, et al. (2022). Assessing efficacy and use patterns of medical cannabis for symptom management in elderly cancer patients. Am J Hosp Palliat Care. (Among 85 cancer patients ages 65 years and above who were treated with medical cannabis products [containing both THC and CBD] who filled out symptom questionnaires before and during therapy, there were slight decreases but not statistically significant changes in pain, nausea, anorexia or anxiety; no mention of adverse events, ALT elevations or hepatotoxicity).
Englund A, Oliver D, Chesney E, Chester L, Wilson J, Sovi S, De Micheli A, et al. (2022). Does cannabidiol make cannabis safer? A randomised, double-blind, cross-over trial of cannabis with four different CBD:THC ratios. Neuropsychopharmacology. (Among 47 healthy volunteers given granulated cannabis after pretreatment with one of 3 doses of cannabidiol [20, 30 or 40 mg] or placebo, serum THC concentrations and its cognitive and psychological effects were not affected by CBD pretreatment).
Stolar O, Hazan A, Vissoker RE, Kishk IA, Barchel D, Lezinger M, Dagan A, et al. (2022). Medical cannabis for the treatment of comorbid symptoms in children with autism spectrum disorder: An interim analysis of biochemical safety. Front Pharmacol. (Among 59 children with autistic spectrum disorder treated with cannabidiol in medium chain triglyceride oil in escalating doses for an average of 18 weeks, there were no clinical or statistically significant changes in complete blood counts or chemistry tests including ALT, AST, Alk P).
Pinazo-Bandera JM, García-Cortés M, Segovia-Zafra A, Lucena MI, Andrade RJ. (2022). Recreational drugs and the risk of hepatocellular carcinoma. Cancers (Basel). (Review of the association of hepatocellular carcinoma with recreational drug use, including Khat, kava kava, cannabis, cigarette smoking, cocaine, heroin, amphetamines and anabolic steroids, states that the association of marijuana use with liver cancer is controversial and meta-analyses have concluded that cannabis use is not associated with worsening of liver fibrosis).
Barré T, Bourlière M, Ramier C, Carrat F, Di Beo V, Protopopescu C, Marcellin F, et al., Anrs/Afef Hepather Study Group. (2022). Cannabis use is inversely associated with metabolic disorders in hepatitis C-infected patients (ANRS CO22 Hepather Cohort). J Clin Med. (Among 6464 adults with chronic hepatitis C enrolled in a French national cohort study, 12% were current users and 20% former users of marijuana, and in multivariate analysis, the cannabis users were less likely to have hypertension and multiple metabolic conditions such as obesity and diabetes, suggesting that marijuana use is protective against metabolic dysregulation).
Kanjanarangsichai A, Mitarnun W, Mitarnun W, Pangwong W, Laoharattanahirun N, Kajornrith W, Junlaor P, et al. (2022). Cannabidiol-enriched cannabis extraction product in Parkinson's disease: a randomized, double-blind, and placebo-controlled trial in Buriram Hospital. J Neurosci Rural Pract. (Among 40 patients with Parkinson disease treated with a sublingual cannabinoid product [16 mg of cannabidiol and 0.6 mg of THC daily] for 8 weeks, there were no differences in measures of Parkinson disease symptoms and signs and no differences in serum ALT, AST, Alk P and bilirubin levels between the two groups).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while marijuana and cannabis were not implicated in any cases).
Pillai M, Erridge S, Bapir L, Nicholas M, Dalavaye N, Holvey C, Coomber R, et al. (2022). Assessment of clinical outcomes in patients with post-traumatic stress disorder: analysis from the UK Medical Cannabis Registry. Expert Rev Neurother. (Among 162 patients enrolled in the UK Medical Cannabis Registry who were treated for post-traumatic stress disorder, improvements in PTSD symptoms occurred with therapy and adverse events were reported in 20% of patients including fatigue, insomnia and dizziness but with no reports of liver injury).
Vickery AW, Roth S, Ernenwein T, Kennedy J, Washer P. (2022). A large Australian longitudinal cohort registry demonstrates sustained safety and efficacy of oral medicinal cannabis for at least two years. PLoS One. (Among 3961 patients in an Australian longitudinal registry of patients treated with medicinal cannabis for at least 2 years, improvements in symptoms were rapid and sustained for two, during which 37% had at least one adverse event including somnolence [11%], dry mouth [9%], lethargy [6%], dizziness [6%] and nausea [5%], without mention of liver related adverse events or ALT elevations).
Gelow K, Chalasani S, Green K, Lammert C. (2022). Utilization and impact of complementary and alternative medicines in symptomatic autoimmune hepatitis patients. Dig Dis Sci. (Among patients with autoimmune hepatitis who completed an on-line questionnaire, 45% reported using CBD oil after the diagnosis was made usually for fatigue, pain, disturbed sleep, or itching).
Olsson F, Erridge S, Tait J, Holvey C, Coomber R, Beri S, Hoare J, et al. (2023). An observational study of safety and clinical outcome measures across patient groups in the United Kingdom Medical Cannabis Registry. Expert Rev Clin Pharmacol. (Among 2833 persons enrolled in the UK Medical Cannabis Registry between 2019 and 2022, indications for treatment included non-cancer pain [32%], anxiety [11%], fibromyalgia [11%], neuropathy [8%]. PTSD [6%] and depression [5%], health related quality of life improved after 1 month and was improved in all subscales except self-care at 12 months, the most common therapies were THC oil [20 mg/mL] and CBD oil [50 mg/mL]; adverse events being reported by 17% of patients which were usually mild or moderate [79%], most commonly fatigue [14%], dry mouth [12%], somnolence [11%] insomnia [11%] headache [10%], impaired concentration [10%], nausea [9%], and dizziness [8%]; no mention of ALT elevations or liver injury).
Morris M, Chye R, Liu Z, Agar M, Razmovski-Naumovski V. (2023). A retrospective medical record review of adults with non-cancer diagnoses prescribed medicinal cannabis. J Clin Med. (Among 157 adults treated with medicinal cannabis [typically balanced THC/CBD oil] at a single specialty clinic after its approval in Australia, the major reasons were for pain [87%], muscle spasm [12%] and sleep [6%] and its was considered beneficial by the patient in 54%, most frequently for neuropathy [67%], Parkinson disease [61%], multiple sclerosis [60%], migraine [44%], chronic pain syndrome [42% and spondylosis [40%], and specifically for sleep [80%], fatigue [52%], and pain [50%]; side effects were reported in 43% of patients and were generally mild including somnolence, dry mouth and confusion; no mention of ALT elevations or liver injury).
Waissengrin B, Leshem Y, Taya M, Meiri D, Merimsky O, Shamai S, Wolf I, Rubinek T. (2023). The use of medical cannabis concomitantly with immune checkpoint inhibitors in non-small cell lung cancer: A sigh of relief?. Eur J Cancer. (Among 201 adults with metastatic non-small cell lung cancer treated with pembrolizumab as a first line therapy, 51% were prescribed cannabis products for cancer symptoms [mostly pain and poor appetite], but time to tumor progression was similar with or without cannabis therapy and overall survival was numerically but not statistically better in the cannabis treated subjects; no mention of side effects, ALT levels or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Cannabis: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cannabis+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Cannabis: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cannabis)